# Amantadine

## OVERVIEW

### Introduction

Amantadine is a primary amine that has both antiviral and dopaminergic activity and is used in the therapy of influenza A and management of Parkinson disease. Amantadine has not been associated with clinically apparent liver injury.

### Background

Amantadine (a man' ta deen) is a cyclic primary amine that has antiviral and anti-Parkinsonian activities. The antiviral activity of amantadine is attributed to inhibition of virion uncoating and release of viral RNA in the initial stages of viral replication. Amantadine is active only against influenza A virus and has no activity against influenza B or other upper respiratory viruses. In addition, resistance to amantadine (with cross resistance to rimantadine) can develop rapidly and is now common. The anti-Parkinsonian activity of amantadine appears to be due to its effects on release of dopamine in the substantia nigra. Amantadine is indicated for therapy of influenza A and in management of Parkinson disease and extrapyramidal reactions. Amantadine was approved for use in the United States in 1968 and is currently used both for influenza and Parkinson disease. Amantadine is available as capsules or tablets of 100 mg and as oral syrup generically and under the brand name of Symmetrel. The recommended oral dose for treatment of influenza in adults is 200 mg daily until symptoms have resolved; amantadine can also be administered as prophylaxis as soon as possible after close personal exposure. The dose in Parkinson disease is 100 to 400 mg daily in divided doses. Side effects include anxiety, dizziness, ataxia, confusion, fatigue, headache, insomnia, dry mouth and gastrointestinal upset. Rare potentially severe adverse events include convulsions, depression, suicidal ideation and behavior, acute psychosis, heart failure and hypersensitivity reactions.

### Hepatotoxicity

Despite widespread use, there is little evidence that amantadine when given orally causes liver injury, either in the form of serum enzyme elevations or clinically apparent liver disease.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Amantadine has minimal hepatic metabolism and is excreted largely unchanged in the urine, factors which perhaps explain the absence of significant hepatotoxicity.

Drug Classes: Antiviral Agents; Antiparkinson Agents

Other Drugs in the Class for Influenza: Baloxavir, Oseltamivir, Peramivir, Rimantadine, Zanamivir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amantadine – Generic, Symmetrel®

DRUG CLASS

Antiviral Agents; Antiparkinson Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Amantadine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Amantadine | 768-94-5 | C10-H17-N

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2020

Zimmerman HJ. Antiviral agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 621-3. (Expert review of antiviral agents and liver injury published in 1999; mentions that both amantadine and rimantadine have "no adverse effect on the liver").
Núñez M. Influenza virus treatments. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 513. (Review of hepatotoxicity of antiviral agents; amantadine has been linked to rare instances of liver enzyme elevations).
Acosta EP. Antiviral agents (nonretroviral). In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1105-18. (Textbook of pharmacology and therapeutics).
Schnack H, Wewalka F, Guttmann G. (1969). Liver function during amantadine hydrochloride medication in compensated liver disease. Int Z Klin Pharmakol Ther Toxikol. (Placebo controlled trial of 4 weeks of amantadine in 25 patients with cirrhosis showed no difference in ALT, AST, Alk P or bilirubin levels during therapy).
Styrt B, Freiman JP. (1995). Hepatotoxicity of antiviral agents. Gastroenterol Clin North Am. (Review of liver toxicity of antiviral agents mentions that there is little information on the potential hepatotoxicity of amantadine and the product label does not mention liver injury).
Jefferson T, Demicheli V, Di Pietrantonj C, Rivetti D. (2006). Amantadine and rimantadine for influenza A in adults. Cochrane Database Syst Rev. (Systematic review of efficacy of amantadine and rimantadine in treatment and prevention of influenza A; side effects are frequent, but largely consist of dizziness, insomnia, lightheadedness and headache; no mention of liver tests abnormalities or hepatitis).
Crosby N, Deane KH, Clarke CE. (2003). Amantadine in Parkinson's disease. Cochrane Database Syst Rev. (Systematic review of efficacy of amantadine in treatment of Parkinson disease; side effects are frequent, but largely consist of dizziness, insomnia, lightheadedness and headache; no mention of liver test abnormalities or hepatitis).
(2007). Drugs for non-HIV viral infections. Treat Guidel Med Lett. (Review of status of non-antiretroviral antiviral agents for prevention and treatment of herpes, varicella-zoster, cytomegalovirus, influenza A and B, and hepatitis B and C; no mention of liver related side effects for amantadine).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008; 8 were attributed to antiviral agents but none to amantadine or other antiinfluenza medications).
(2013). Antiviral drugs. Treat Guidel Med Lett. (Review of status of non-antiretroviral antiviral agents; because of the high rate of resistance of influenza A virus isolates to amantadine and rimantadine, they are not currently recommended either for prevention or treatment of influenza; no discussion of side effects).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no case was attributed to amantadine or any other drug for either Parkinson disease or influenza).
(2019). Antiviral drugs for treatment and prophylaxis of seasonal influenza. Med Lett Drugs Ther. (Concise review of the drug therapy of influenza mentions that there are no data suggesting the superiority of one neuraminidase inhibitor over another, they are all approved for treatment of uncomplicated influenza, should be started as soon as possible, and have been shown to shorten the duration of symptoms by one day in adults; mentions that rimantadine and amantadine are no longer recommended for treatment of influenza because of high rates of resistance in circulating strains of influenza A and they are ineffective against influenza B).
(2020). Antiviral drugs for influenza. Med Lett Drugs Ther. (Concise review of the drug therapy of influenza mentions that there is no evidence that one neuraminidase inhibitor or baloxavir is more effective than any other in treating uncomplicated influenza infections, but that oseltamivir is preferred for treatment of pregnant women, hospitalized patients and those with severe, complicated or progressive illness; mentions that rimantadine and amantadine are no longer recommended for treatment of influenza because of high rates of resistance in circulating strains of influenza A and they are ineffective against influenza B).

## OTHER REFERENCE LINKS

1 Recent References on Amantadine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Amantadine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Amantadine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Amantadine)